# Propantheline

## OVERVIEW

### Introduction

Propantheline is an anticholinergic agent used to treat gastrointestinal conditions associated with intestinal spasm and to decrease secretions during anesthesia. Propantheline has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Propantheline (proe pan' the leen) is a synthetic quaternary ammonium anticholinergic agent which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, decreasing respiratory and gastrointestinal secretions and intestinal motility. Propantheline has broad activity against muscarinic acetylcholine receptors, but its highly polar quaternary ammonium group makes it less likely to cross lipid membranes such as the blood brain barrier, which is believed to decrease the potential for central nervous system effects. Propantheline has been used largely to alleviate symptoms of irritable bowel syndrome, painful gastrointestinal motility disorders and acid-peptic ulcer disease. Propantheline was approved for use in the United States in 1953 but is now not commonly used, having been replaced by more effective antiulcer agents. Propantheline is available in tablets of 7.5 and 15 mg in generic forms and under the brand name Pro-Banthine. The typically recommended oral dose in adults is 7.5 to 15 mg three times daily and 30 mg at bedtime. Common side effects are those of parasympathetic stimulation and include dryness of the mouth and eyes, decreased sweating, headache, visual blurring, constipation, and urinary retention. Because of its structure, propantheline is believed to be less likely than other anticholinergics to cross the blood brain barrier and cause central nervous system effects such as restlessness, confusion and hallucinations. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Like other anticholinergic agents, propantheline has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. It is metabolized at least partially in the liver. A reason for its safety may relate to the low daily dose.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on Anticholinergic Agents.

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Propantheline – Generic, Pro-Banthine®

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Propantheline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Propantheline | 50-34-0 | C23-H30-N-O3.Br | Propantheline Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Propantheline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Propantheline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Propantheline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Propantheline)